# Cangrelor

## OVERVIEW

### Introduction

Cangrelor is an intravenously administered antiplatelet drug that is used at the time of cardiac surgery or percutaneous coronary intervention to decrease the risk of myocardial infarction and maintain artery and stent patency. Cangrelor has not been linked to serum enzyme abnormalities or to clinically apparent liver injury, but its clinical use has been limited.

### Background

Cangrelor (kan' grel or) is a non-thienopyridine, reversible inhibitor of adenosine diphosphate (ADP) receptors (P2Y 12) on platelets and is used to decrease the risk of recurrent coronary thromboses in patients who undergo coronary interventions. Activated platelets release ADP which binds to ADP platelet receptors, causing activation of intracellular glycoprotein IIb/IIIA complex which triggers platelet adherence and aggregation. The aggregation of platelets plays an important role in the growth of atheromatous plaques, which can lead to coronary, cerebral and peripheral arterial occlusions. Cangrelor has a rapid onset of action and short-half life, making it an appropriate agent for short term intravenous use. In clinical trials, cangrelor therapy during acute coronary events (unstable angina and myocardial infarction) was shown to decrease the frequency of recurrence of myocardial infarction and stent thromboses. Cangrelor was approved for use in the United States in 2015 and current indications are reduction of recurrent cardiovascular events in patients with acute coronary syndromes. Cangrelor is available in single use vials of 50 mg of lyophilized powder for reconstitution under the commercial name Kengreal. The usual dose regimen is a bolus of 30 µg/kg before the procedure followed by 4 µg/kg/min for at least 2 hours or the duration of the procedure. Side effects are not common, but can include excess bleeding, dyspnea and hypersensitivity reactions.

### Hepatotoxicity

In several large clinical trials, serum ALT elevations were no more frequent with cangrelor therapy than with placebo [9% vs 12%] or with comparator arms [6.6% vs 6.8%] and no cases of clinically apparent liver injury with jaundice were reported. In addition, since marketing and release, there have been no published reports of clinically apparent liver injury or jaundice associated with cangrelor therapy and hepatotoxicity is not mentioned in the product label.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Cangrelor, unlike clopidogrel, does not require metabolic activation for its antiplatelet effects. Cangrelor is metabolized in the liver predominantly via CYP 3A4 and it should be used with caution in patients taking CYP 3A4 inhibitors which can increase serum levels, or CYP 3A4 inducers which can decrease drug levels.

### Outcome and Management

There is little evidence that cangrelor can cause liver injury or has any cross sensitivity to other antiplatelet agents.

Drug Class: Antithrombotic Agents, Antiplatelet Agents

Other Drugs in the Subclass, Antiplatelet Agents: Aspirin, Clopidogrel, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cangrelor – Generic, Kengreal®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cangrelor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cangrelor | 163706-06-7 | C17-H25-Cl2-F3-N5-O12-P3-S2 | Cangrelor chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 October 2017

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 641-3. (Textbook of hepatotoxicity published in 1999; ticlopidine, but not clopidogrel, prasugrel, cangrelor or ticagrelor is discussed).
De Marzio DH, Navarro VJ. Antiplatelet agents. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 527-8. (Review of hepatotoxicity of antiplatelet drugs discusses ticlopidine, clopidogrel and prasugrel, but does not mention ticagrelor or cangrelor).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Greenbaum AB, Ohman EM, Gibson CM, Borzak S, Stebbins AL, Lu M, Le May MR, et al. Preliminary experience with intravenous P2Y12 platelet receptor inhibition as an adjunct to reduced-dose alteplase during acute myocardial infarction: results of the Safety, Tolerability and Effect on Patency in Acute Myocardial Infarction (STEP-AMI) angiographic trial. Am Heart J 2007; 154: 702-9. (Among 92 patients undergoing coronary artery fibrolytic therapy given alteplase, cangrelor or both, patency was more frequent with alteplase [50%] and alteplase and cangrelor [55%] than cangrelor alone [18%]; no mention of ALT elevations or hepatotoxicity). 17892995
Angiolillo DJ, Firstenberg MS, Price MJ, Tummala PE, Hutyra M, Welsby IJ, Voeltz MD, et al.; BRIDGE Investigators. Bridging antiplatelet therapy with cangrelor in patients undergoing cardiac surgery: a randomized controlled trial. JAMA 2012; 307: 265-74. (Among 210 patients undergoing coronary artery bypass surgery treated with cangrelor as a bridge from oral antiplatelet therapy, ALT elevations above 3 times ULN were similar in the group [2.3% vs 3.8%]). 22253393
Steg PG, Bhatt DL, Hamm CW, Stone GW, Gibson CM, Mahaffey KW, Leonardi S, et al.; CHAMPION Investigators. Effect of cangrelor on periprocedural outcomes in percutaneous coronary interventions: a pooled analysis of patient-level data. Lancet 2013; 382 (9909): 1981-92. (A pooled analysis of 3 controlled trials of cangrelor therapy during percutaneous coronary interventions in 24,910 patients, found a reduction in thrombotic events with cangrelor therapy despite similar rates of serious adverse events in both groups [2.2% in each], the only side effect more frequent with cangrelor being dyspnea [1.1% vs 0.4%]). 24011551
Bhatt DL, Stone GW, Mahaffey KW, Gibson CM, Steg PG, Hamm CW, Price MJ, et al.; CHAMPION PHOENIX Investigators. Effect of platelet inhibition with cangrelor during PCI on ischemic events. N Engl J Med 2013; 368: 1303-13. (Among 11,145 patients undergoing percutaneous coronary interventions who received cangrelor or clopidogrel, thrombotic events within 48 hours were less frequent with cangrelor [4.7% vs 5.9%] and adverse event rates were low; no mention of ALT elevations or hepatotoxicity). 23473369
Antithrombotic drugs. Med Lett Drugs Ther 2014; 56: 103-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/?term=25337986) (Guidelines on use of antiplatelet agents including aspirin, clopidogrel, prasugrel and ticagrelor does not discuss cangrelor).
Abtan J, Steg PG, Stone GW, Mahaffey KW, Gibson CM, Hamm CW, Price MJ, et al.; CHAMPION PHOENIX Investigators. Efficacy and safety of cangrelor in preventing periprocedural complications in patients with stable angina and acute coronary syndromes undergoing percutaneous coronary intervention: The CHAMPION PHOENIX Trial. JACC Cardiovasc Interv 2016; 9: 1905-13. (Subgroup analysis of the CHAMPION trial [Bhatt 2013] demonstrated a consistent beneficial effect of cangrelor compared to clopidogrel in patients with stable angina and in those with an acute coronary syndrome; no discussion of adverse events). 27659566

## OTHER REFERENCE LINKS

1. Recent References on Cangrelor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=aspirin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cangrelor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aspirin)